# Purine Analogues

## OVERVIEW

### Introduction

The purine analogues used as antineoplastic agents are a group of agents with similar structures, but somewhat different mechanisms of action, pharmacokinetics, indications and adverse effects. These agents are nucleoside analogues and are considered antimetabolites, interfering or competing with nucleoside triphosphates in the synthesis of DNA or RNA or both. The agents are analogues of adenine or guanine and generally have excellent activity against leukemias and lymphomas, perhaps because of their preferential uptake, activation and effects in lymphoid tissue.

The thiopurines include mercaptopurine, azathiopurine and thioguanine, which are active against several forms of leukemia and are also used as immunosuppressive and immunomodulatory agents in the treatment of autoimmune conditions (Crohn disease, autoimmune hepatitis, lupus nephritis) and in regimens to prevent transplant rejection. All three agents are generally well tolerated and commonly used in cancer chemotherapy as well as autoimmune conditions.

The other antineoplastic purine analogues are used almost exclusively for malignant conditions, typically leukemia or lymphomas. Fludarabine is the most commonly used of these purine analogues and is a first line agent in the treatment of chronic lymphocytic leukemia. Fludarabine also has profound immunosuppressive activity and is used in nonmyeloablative regimens in preparation for hematopoietic cell transplantation. Because of its immunosuppressive activity, fludarabine is associated with reactivation of viral infections, including hepatitis B. Cladribine and pentostatin are adenosine derivatives and are used predominantly for hairy cell leukemia. They have minimal hepatotoxic potential, at least at the doses that are used to treat hairy cell leukemia. Clofarabine is also an adenosine derivative and is used as therapy of acute lymphoblastic leukemia, mostly in children who have failed previous therapies. Nelarabine is a guanine derivative and is used in T cell malignancies, usually after failure of prior therapies. Both of these agents are associated with high rates of serum aminotransferase elevations during therapy, but are very rare causes of clinically apparent liver injury.

Thus, all of the purine analogues have some degree of direct hepatotoxic potential. In the doses and regimens in current use, this hepatotoxicity is generally mild and manifested only by transient, mild-to-moderate serum aminotransferase elevations. For many of these agents, however, more clinically apparent liver injury has been described, particularly with mercaptopurine and azathioprine.

Each of the antineoplastic purine analogues are discussed separately and with their specific references. Links to the individual drug records are given below.

- Azathioprine
- Cladribine
- Clofarabine
- Fludarabine
- Mercaptopurine
- Nelarabine
- Pentostatin
- Thioguanine

Drug Class: Antineoplastic Agents, Antimetabolites